# Pralatrexate

## OVERVIEW

### Introduction

Pralatrexate is a parenterally administered folate antagonist and antineoplastic agent, used in the treatment of peripheral T cell lymphomas. Pralatrexate has been associated with a modest rate of serum enzyme elevations during therapy, but has not been convincingly linked to instances of acute, clinically apparent liver injury.

### Background

Pralatrexate (pral" a trex' ate) is a folate analogue which acts as an antagonist to the enzymes involved in folate dependent synthetic pathways such as thymidine synthase, dihydrofolate reductase and glycinamide ribonucleotide formyltransferase. Inhibition of these enzymes leads to decrease in intracellular concentrations of thymidine and purine which blocks RNA and DNA synthesis and leads to apoptotic cell death in rapidly dividing cells. In vitro and in vivo studies have shown that pralatrexate has activity against peripheral T cell lymphomas, and it was approved for this use in the United States in 2009. Current indications are limited to patients with refractory or relapsed peripheral T cell lymphoma. Pralatrexate is available in single use vials of 20 or 40 mg as a solution for injection under the brand name Folotyn. The recommended dose is 30 mg/m^2^ given intravenously once weekly for 6 weeks in 7 week cycles. Pralatrexate shares common side effects with other folate antagonists such as nausea, vomiting, diarrhea, alopecia, bone marrow suppression, peripheral neuropathy and rash. Uncommon, but potentially serious adverse events include febrile neutropenia, infections, dehydration, renal failure, arrhythmias and peripheral neuropathy.

### Hepatotoxicity

Pralatrexate is associated with serum enzyme elevations during therapy, but these abnormalities are generally mild and self-limited, rising to above 5 times ULN in 2% to 6% of patients and rarely requiring dose adjustment. No instances of clinically apparent acute liver injury attributed to pralatrexate have been reported in the literature, but monitoring for liver toxicity is recommended. Pralatrexate has not been linked specifically to sinusoidal obstruction syndrome, but it is rarely used in high doses in neoplastic disease or in conditioning regimens for bone marrow transplantation, situations in which alkylating agents are commonly associated with this complication.

Likelihood score: E* (unlikely but suspected rare cause of liver injury).

### Mechanism of Injury

The cause of the serum enzyme elevations that may occur during pralatrexate use is probably direct hepatotoxicity from the folate antagonism. Its hepatic metabolism by the microsomal P450 system is minimal and much of the administered drug is excreted unchanged in the urine.

### Outcome and Management

Liver injury is rare after pralatrexate therapy. Confirmed serum enzyme elevations above 5 times ULN should lead to temporary discontinuation of pralatrexate therapy or adjustment of dose, but should also lead to careful search for other possible causes of liver injury. There have been no instances of acute liver failure, chronic hepatitis or vanishing bile duct syndrome linked to pralatrexate therapy.

Drug Class: Antineoplastic Agents, Antifolate Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Pralatrexate – Folotyn®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Pralatrexate)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Pralatrexate | 146464-95-1 | C23-H23-N7-O5 | Pralatrexate chemical structure
Folate | 6484-89-5 | C19-H18-N7-O6.Na | Folate chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: 01 May 2016

Zimmerman HJ. Oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 673-708. (Expert review of hepatotoxicity of cancer chemotherapeutic agents published in 1999; pralatrexate is not discussed).
DeLeve LD. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 549-68. (Review of hepatotoxicity of cancer chemotherapeutic agents; pralatrexate is not discussed).
Chabner BA, Bertino J, Clearly J, Ortiz T, Lane A, Supko JG, Ryan DP. Cytotoxic agents. Chemotherapy of neoplastic diseases. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1315-404. (Textbook of pharmacology and therapeutics).
Malik SM, Liu K, Qiang X, Sridhara R, Tang S, McGuinn WD Jr, Verbois SL, et al. Folotyn (pralatrexate injection) for the treatment of patients with relapsed or refractory peripheral T-cell lymphoma: U.S. Food and Drug Administration drug approval summary. Clin Cancer Res 2010; 16: 4921-7. (Basis for accelerated approval of pralatrexate for PTCL; among 111 patients with relapsed or refractory PTCL treated, the response rate to pralatrexate therapy was 27% and common side effects were thrombocytopenia, mucositis, neutropenia, nausea and fatigue; no mention of ALT elevations or hepatotoxicity). 20739433
Azzoli CG, Patel JD, Krug LM, Miller V, James L, Kris MG, Ginsberg M, et al. Pralatrexate with vitamin supplementation in patients with previously treated, advanced non-small cell lung cancer: safety and efficacy in a phase 1 trial. J Thorac Oncol 2011; 6: 1915-22. (Among 39 patients with refractory NSCLC treated with pralatrexate [150-325 mg/m^2^ every 2 weeks] with folic acid and B12 supplementation, the overall response rate was only 10% and side effects were common, but ALT elevations above 5 times ULN occurred in only one patient [2.6%]). 21841501
Cheson BD, Horwitz SM, Weisenburger DD. Peripheral T-cell lymphomas: diagnosis and treatment options. Proceedings from a live roundtable, August 17, 2011, Kauai, Hawaii. Clin Adv Hematol Oncol 2011; 9 (11 Suppl 26): 1-14. (Review of the challenges in diagnosis and management of PTCL). 22362328
O'Connor OA, Pro B, Pinter-Brown L, Bartlett N, Popplewell L, Coiffier B, Lechowicz MJ, et al. Pralatrexate in patients with relapsed or refractory peripheral T-cell lymphoma: results from the pivotal PROPEL study. J Clin Oncol 2011; 29: 1182-9. (Among 111 patients with refractory or relapsing PTCL treated with pralatrexate, the overall response rate was 29% and common severe side effects included thrombocytopenia [32%], mucositis [22%], neutropenia [22%], anemia [18%] and liver test abnormalities [13%] which were greater than 5 times ULN in 5% and led to dose modification in 2%). 21245435
Marchi E, O'Connor OA. Safety and efficacy of pralatrexate in the treatment of patients with relapsed or refractory peripheral T-cell lymphoma. Ther Adv Hematol 2012; 3: 227-35. (Review of the structure, mechanism of action, development, clinical efficacy and safety of pralatrexate as therapy of PTCL mentions that side effects can include “mild abnormalities of liver function tests”). 23606933
Kelly K, Azzoli CG, Zatloukal P, Albert I, Jiang PY, Bodkin D, Pereira JR, et al. Randomized phase 2b study of pralatrexate versus erlotinib in patients with stage IIIB/IV non-small-cell lung cancer (NSCLC) after failure of prior platinum-based therapy. J Thorac Oncol 2012; 7: 1041-8. (Among 201 patients with refractory NCSLC treated with pralatrexate [190 mg/m^2^ every 2 weeks], or erlotinib, response and survival rates were similar, but pralatrexate was associated with higher rates of treatment related severe adverse events [14% vs 2%] and discontinuation for adverse events [33% vs 10%]; no mention of ALT elevations or hepatotoxicity). 22534814
Advani RH, Ansell SM, Lechowicz MJ, Beaven AW, Loberiza F, Carson KR, Evens AM, et al. A phase II study of cyclophosphamide, etoposide, vincristine and prednisone (CEOP) Alternating with Pralatrexate (P) as front line therapy for patients with peripheral T-cell lymphoma (PTCL): final results from the T- cell consortium trial. Br J Haematol 2016; 172: 535-44. (Among 33 patients with PTCL receiving pralatrexate alternating with standard therapies, the overall response rate was 70%; toxicities were common and included ALT or AST elevations above 5 times ULN in 4 patients [12%]). 26627450

## OTHER REFERENCE LINKS

1. Recent References on Pralatrexate: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Pralatrexate+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Pralatrexate: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Pralatrexate)